# Sinusoidal Obstruction Syndrome (Veno-occlusive Disease)

Definition. Sinusoidal obstruction syndrome (SOS), previously known as veno-occlusive disease (VOD), is a distinctive and potentially fatal form of hepatic injury that occurs predominantly, if not only, after drug or toxin exposure. SOS can present in an acute, subacute or chronic form usually with abdominal pain and swelling, with evidence of portal hypertension and variable degrees of serum enzyme elevations and jaundice. Liver histology demonstrates obstruction of sinusoids in central areas with hepatocyte necrosis and hemorrhage.

Latency to Onset. The acute form of SOS presents within 1 to 3 weeks of exposure to the medication (which can be a single infusion). The subacute and chronic forms of SOS present weeks, months or even years after starting.

Symptoms. Acute SOS typically presents with abdominal pain and swelling, weight gain and signs of portal hypertension (ascites, edema, varices). Jaundice is generally mild or absent initially, but may develop and worsen if the injury is severe. The subacute and chronic forms of SOS typically present with fatigue and abdominal swelling with signs and symptoms of portal hypertension including edema, ascites, varices, hepatic encephalopathy or muscle wasting and weakness.

Serum Enzyme Elevations. Acute SOS can present with a hepatocellular pattern of serum enzyme elevations with marked increases in ALT and AST (>10 times ULN) and mild or minimal increases in alkaline phosphatase. However, in some situations, serum enzymes are minimally or not elevated and patients present with ascites, fluid overload, signs of hepatic failure and progressive jaundice. In chronic SOS, serum enzymes are modestly elevated and are either hepatocellular or mixed.

Drugs. Agents that cause SOS include cancer chemotherapeutic agents, particularly the alkylating agents such as busulfan, cyclophosphamide, melphalan, carmustine (BCNU), thiotepa, dacarbazine, and the platinum coordination complexes - carboplatin, cisplatin and oxaliplatin. The thiopurines, such as azathioprine, mercaptopurine and thioguanine, have also been implicated in rare cases of SOS, usually when given in high doses in combination with other agents. Finally, the pyrrolizidine alkaloids which are found in many plants and shrubs are well known causes of SOS, this exposure being linked usually to bush tea, and instances of contamination of food sources such as rice or wheat with pyrrolizidine containing weeds or plants.

Differential Diagnosis. The diagnosis of SOS usually rests on a typical clinical presentation and exclusion of other causes of liver injury. In the setting of bone marrow transplantation [currently referred to as hematopoietic cell transplantation], the usual differential diagnosis includes graft-vs-host disease, sepsis, other forms of drug induced liver injury and unusual forms of viral hepatitis (herpes simplex). The diagnosis is usually supported by imaging demonstrating changes typical of sinusoidal obstruction. Liver biopsy is diagnostic but not usually needed and difficult because of concurrent coagulopathy or thrombocytopenia.

Clinical Features and Outcome. Sinusoidal obstruction syndrome can be classified as acute, subacute or chronic in presentation. Acute presentation is typically with sudden onset of hepatomegaly, abdominal pain, fluid retention, jaundice and ascites. Serum aminotransferase levels are usually high, with minimal increase in alkaline phosphatase. The peak of ALT elevations occur days or weeks after initial presentation. This syndrome is fatal in 20% to 50% of patients with SOS, due to high dose chemotherapy or chemoradiation regimens used in preparation of hematopoietic cell transplantation. In nonfatal cases, recovery usually proceeds over 50 to 100 days. The rapid onset of weight gain and jaundice, extreme elevations in serum ALT levels and presence of renal or respiratory failure are poor prognostic signs.

Subacute and chronic veno-occlusive disease usually occurs with chronic low dose ingestion of pyrrolizidine alkaloids or oral chemotherapeutic agents (such as thioguanine). Patients present with the insidious onset of fatigue, abdominal distension and signs and symptoms of portal hypertension. Cirrhosis may be present at the time of clinical presentation.

The clinical features and course of sinusoidal obstruction syndrome has been most clearly defined in the setting of hematopoietic cell transplantation after conditioning with cytotoxic agents or chemoradiation. The onset of sinusoidal obstruction syndrome is typically within 10 to 20 days after transplantation. However, with less aggressive regimens and cancer chemotherapy it can arise as much as 3 to 6 weeks after starting therapy. The typical presentation is onset of unexplained weight gain within a week of transplantation, followed by abdominal or right upper quadrant pain and tenderness, abdominal distention due to ascites, and jaundice. Depending upon the severity of the injury, the onset can be abrupt and associated with sudden onset of severe abdominal pain and rapid progression to hepatic and multiorgan failure or be more insidious with appearance of tender hepatomegaly, mild weight gain and serum enzyme elevations with mild or minimal jaundice. The clinical syndrome is similar to Budd Chiari syndrome (hepatic vein thrombosis), but the obstruction is due to narrowing and occlusion of sinusoids and small hepatic venules rather than thrombosis of the larger hepatic veins. At least 80% of patients with sinusoidal obstruction syndrome recover.

The most common form of SOS is a complication of cancer chemotherapy and is typically found after use of high doses of alkylating agents (busulfan, cyclophosphamide, melphalan, carmustine) and total body irradiation, most commonly when they are used in combination myeloablative regimens in preparation for hematopoietic cell transplantation. These regimens are meant to cause toxic cell death to malignant hematopoetic cells as well as ablate the host immune system to allow for engraftment of an allogenic hematopoietic cells. The high doses used, however, can also injure normal cells, the sinusoidal endothelial cells being particularly vulnerable. SOS can also occur after administration of single chemotherapeutic agents in nonmyeloablative doses, such as with cyclic intravenous infusions of dacarbazine (DTIC), gemtuzumab (a toxin conjugated anti-CD33 monoclonal antibody), oxaliplatin and carboplatin and, rarely, other single chemotherapy drugs. Chronic administration of the antimetabolites 6-thioguanine, azathioprine and mercaptopurine can also cause SOS, although the presentation is typically subacute or chronic.

Diagnosis. After cancer chemotherapy or conditioning for hematopoietic cell transplantation, SOS can often be diagnosed based upon clinical symptoms, signs and routine laboratory tests. Liver histology is diagnostic but not always practicable, because of the thrombocytopenia and neutropenia present after chemotherapy or myeloablation. Transjugular liver biopsy and concurrent measurement of the hepatic venous pressure gradient is perhaps the most reliable means of diagnosis and grading for severity (based upon the presence and degree of portal hypertension).

In clinical situations, SOS is usually diagnosed using established criteria of liver injury arising within 20 days of bone marrow transplantation with at least two of the following: (1) rise of serum bilirubin above 2.0 mg/dL, (2) hepatomegaly and/or tenderness or pain over the liver, and (3) sudden weight gain (>2% of body weight) attributable to fluid accumulation. Other possible diagnoses in this situation include graft-vs-host disease, septicemia, viral hepatitis, heart failure or tumor infiltration of the liver, all of which can usually be excluded by clinical, biochemical or radiological features. Prospective application of these criteria has been found to be 85% to 95% sensitive and similarly specific for this diagnosis. Some regimens have resulted in a delayed appearance of SOS after myeloablation (20 to 35 days), and the syndrome can arise after a second, third or later cycle of chemotherapy. Furthermore, the routine use of ursodiol as prophylaxis against SOS appears to be associated with lesser degrees of jaundice and perhaps a milder course of illness. Ultrasound examination of the liver can suggest this diagnosis by demonstrating hepatomegaly, ascites and changes in liver texture suggestive of congestion. In addition, ultrasound can help to exclude acute Budd Chiari syndrome and portal vein thrombosis by the demonstration of patency of large hepatic and portal veins. Doppler ultrasound can demonstrate evidence of portal hypertension, alterations in both portal and hepatic vein flow, and impedance to hepatic artery blood flow. Measurement of the hepatic venous pressure gradient can also demonstrate portal hypertension which may have prognostic value. The reliability of hepatic elastography in assessing SOS deserves prospective analysis.

Mechanisms of Injury. The mechanism of injury in sinusoidal obstruction syndrome is believed to be damage to endothelial cells in the liver followed by their necrosis (apoptosis) and extrusion into sinusoids, leading to obstruction and congestion. Stellate cells become activated and produce extracellular matrix and collagens. Hepatocellular necrosis is probably due to loss of endothelial function, congestion and perhaps direct toxicity of the implicated agents as well. SOS can be produced in animal models, particularly with modulation of glutathione status. The frequency and severity of SOS is at least partially related to drug dosage and pharmacokinetics. Irradiation of the liver can also cause SOS and acts synergistically with antineoplastic agents in causing this syndrome.

Management. The first and most important element in management is to avoid further injury and provide support for complications such as hypotension, electrolyte and acid-base imbalance, renal and pulmonary failure and infectious complications. Anticoagulants have been used based upon the possibility of venous thrombosis, but evidence for benefit is lacking and anticoagulation adds unnecessary complexity of the clinical situation. Infusions of n-acetyl cysteine to replenish glutathione levels may be beneficial as this approach is protective in animal models and is effective in other forms of acute liver failure. Defibrotide, a mixture of porcine oligodeoxyribonucletides with antithrombotic and profibrinolytic features, has been used with promising evidence of benefit. Liver transplantation is rarely indicated in the setting of advanced malignancy and myeloablation.

Prevention of SOS is more likely to be effective than application of therapies after the injury has occurred. Most important is the assessment of the likelihood of SOS and use of chemotherapies and conditioning regimens with lower rates of this complication in patients at highest risk (preexisting liver disease, previous myeloablative therapies and prior liver irradiation). Repletion of glutathione by n-acetyl cysteine or other means may be a reasonable approach to decreasing the rate of SOS after cytotoxic therapy and myeloablation, but glutathione repletion may also decrease the efficacy of the chemotherapy for malignancies. As long as more aggressive cytotoxic therapies are used for advanced cancer, SOS will continue to be a problematic complication. In recent years, the frequency of sinusoidal obstruction syndrome has fallen markedly partially because of the use of less aggressive myeloablative regimens, monitoring of drug levels, appropriate use of pharmacokinetic information and a decrease in chronic hepatitis C among bone marrow recipients, the consequence of introduction of screening of donor blood for anti-HCV and decrease in posttransfusion hepatitis C.

## Representative Cases

### Case 1. Acute veno-occlusive disease and liver failure due to dacarbazine.

[Modified from: Ceci G, Bella M, Melissari M, Gabrielli M, Bocchi P, Cocconi G. Fatal hepatic toxicity of DTIC: Is it really a rare event? Cancer 1985; 61: 1988-91. PubMed Citation]

A 52 year old man with metastatic malignant melanoma developed fever during day 2 of a second cycle of dacarbazine, followed on day 4 by acute abdominal pain and shock. He had tolerated the first cycle of dacarbazine with only mild nausea and vomiting and a few days of fever of 38-39 oC immediately after the 5 day course. At the time of restarting dacarbazine, he was without symptoms and the tumor had decreased in size. On presentation with hepatic injury, he was hypotensive and had tender hepatomegaly. Laboratory tests showed total bilirubin of 2.8 mg/dL, ALT 2050 U/L, AST 2990 U/L, LDH 3270 U/L, alkaline phosphatase 153 U/L, and INR 1.64. Ultrasound of the abdomen showed an enlarged liver and ascites. Acute cholecystitis was suspected and a laparotomy was performed. The gallbladder showed signs of chronic inflammation but no perforation. The liver was enlarged and dark. A liver biopsy showed diffuse centrolobular hepatic necrosis and hemorrhage. After surgery he developed multiorgan failure and progressive hepatic decompensation, dying on hospital day 8. At autopsy, the liver was enlarged and histology showed centrolobular necrosis and hemorrhage with occlusion of small and medium sized hepatic veins.

#### Key Points

Medication: | Dacarbazine, 250 mg/m2 for 5 days every 3 weeks
Pattern: | Hepatocellular (R=~35)
Severity: | 5+ (fatal)
Latency: | 2 days (fever)
Recovery: | None
Other medications: | Metoclopramide for nausea

#### Comment

The acute hepatitis injury attributed to dacarbazine has a very typical clinical presentation and course, with evidence of acute hepatic necrosis as shown by a marked early rise in ALT and LDH with coagulopathy that reverses rapidly if not fatal. The fever and nausea associated with the first course of dacarbazine is also typical. While the pathology demonstrates veno-occlusive disease, there also appears to be an element of acute ischemic necrosis. The rapid appearance on reexposure and the frequent occurrence of fever and eosinophilia suggests a hypersensitivity reaction. In this case, the emergency cholecystectomy only complicated the course.

### Case 2. Mild sinusoidal obstruction syndrome after hematopoietic cell transplantation.

[Data provided by Dr. George B. McDonald from the files of the Fred Hutchinson Cancer Center]

A 56 year old woman with myelofibrosis and agnogenic myeloid metaplasia underwent allogeneic hematopoietic cell transplantation after a conditioning regimen of oral busulfan (16 mg/kg with therapeutic drug monitoring), followed by intravenous cyclophosphamide (120 mg/kg) and prophylactic ursodiol therapy. One week later she became jaundiced and had mild hepatic tenderness. She had gained approximately 10% of her initial body weight. Liver enzyme levels did not change and serum creatinine was stable (0.7 to 1.0 mg/dL). She had complications of staphylococcal bacteremia and pulmonary fungal infection and was treated for gastrointestinal graft-vs-host disease, but responded to antibiotic and antifungal therapy and was discharged 28 days after the transplant at which time her weight was back to baseline.

#### Key Points

Medication: | Busulfan and cyclophosphamide conditioning regimen
Pattern: | Normal ALT and alkaline phosphatase levels
Severity: | 2+ (mild jaundice not prolonging hospitalization)
Latency: | 8 days
Recovery: | 3 weeks
Other medications: | Ursodiol

#### Laboratory Values

Days After Transplant | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
-5 | 13 | 184 | 0.7 | Conditioning
0 | 8 | 187 | 0.6 | Transplant
7 | 10 | 179 | 1.0
8 | 10 | 144 | 4.3 | Peak weight gain
9 | 19 | 135 | 3.0
10 | 16 | 127 | 2.3 | Pleural effusion
11 | 17 | 109 | 2.0
14 | 59 | 108 | 2.0 | GvH disease: prednisone
18 | 21 | 115 | 1.0
28 | 17 | 86 | 1.0 | Weight background
Normal | <49 | <121 | <1.2

#### Comment

The only evidence of sinusoidal obstruction syndrome was the appearance of jaundice with mild hepatic tenderness and weight gain within 1 to 2 weeks of a conditioning regimen for hematopoietic cell transplantation. Careful use of conditioning agents, therapeutic drug monitoring and prophylaxis with ursodiol may have been the reason for the lack of serum enzyme elevations and mild course.

### Case 3. Moderate sinusoidal obstruction syndrome after hematopoietic cell transplantation.

[Data provided by Dr. George B. McDonald from the files of the Fred Hutchinson Cancer Center]

A 48 year old woman with agnogenic myeloid metaplasia underwent allogeneic hematopoietic cell transplantation after a conditioning regimen of oral busulfan (16 mg/kg with therapeutic drug monitoring), followed by intravenous cyclophosphamide (120 mg/kg). A pretransplant liver biopsy showed extramedullary hematopoiesis and sinusoidal fibrosis. One week after transplantation, she became jaundiced and had weight gain and hepatic tenderness. Serum enzyme levels did not change appreciably, but serum creatinine rose (from 1.1 pretransplant to 2.6 by day 30). She developed mild ascites and was treated with defibrotide infusions for suspected sinusoidal obstruction syndrome. Serum bilirubin peaked at 14.4 mg/dL on day 25 and then slowly improved (Table). She was discharged home after 80 days with signs of jaundice and mild portal hypertension.

#### Key Points

Medication: | Busulfan and cyclophosphamide conditioning regimen
Pattern: | Minimal or no ALT and alkaline phosphatase elevations
Severity: | 4+ (jaundice and ascites)
Latency: | 5 days
Recovery: | >12 weeks

#### Laboratory Values

Days After Transplant | ALT (U/L) | Alk P (U/L) | Total Bilirubin (mg/dL) | Other
-5 | 4 | 188 | 0.8
0 | 44 | 167 | 1.2
5 | 27 | 186 | 2.6
10 | 5 | 123 | 4.0
15 | 9 | 114 | 7.0 | Defibrotide started
20 | 10 | 91 | 10.6 | Creatinine 1.6 mg/dL
25 | 52 | 74 | 14.4 | Enterococcal pneumonia
30 | 25 | 120 | 9.7 | Creatinine 2.6 mg/dL
35 | 11 | 107 | 5.2 | Staphylococcal bacteremia
40 | 11 | 80 | 4.7 | Gastric GvHD by biopsy
50 | 19 | 73 | 5.7
60 | 22 | 51 | 3.4
70 | 21 | 48 | 4.6 | CMV viremia, GI bleeding
80 | 15 | 52 | 3.6 | Creatinine 1.8 mg/dL
Normal | <49 | <121 | <1.2

#### Comment

This patient had a recognized risk factor for severe SOS - sinusoidal fibrosis related to extramedullary hematopoiesis. The clinical presentation was typical of SOS with weight gain, jaundice and appearance of ascites and pleural effusions. At the time of discharge, the patient was still jaundiced and had manifestations of portal hypertension (ascites). This case was considered moderate in severity because of marked jaundice and need for defibrotide, but without renal failure requiring dialysis or ventilator failure, which are common in severe SOS. This was an early case of SOS and prophylactic ursodiol was not given.

## Hepatic Histology of Sinusoid Obstruction Syndrome

Liver histology in SOS varies depending upon stage of injury. Early there is dilation of sinusoids and extravasation of red blood cells into the space of Disse (Figure 1). Later there is collagen deposition in sinusoids and small hepatic veins with further congestion, centrolobular (zone 3) necrosis and apparent occlusion of hepatic venules. The sinusoidal injury is not usually distinctive on light microscopy, but the venular lesions are pathognomonic. Typically, the vein lumen is narrowed by infiltration of cells and blood between the endothelium and the collagen of the vein wall (Figure 2). The change is best seen on a Masson trichrome stain, where the blue of the preexisting collagen contrasts with the red fibers of newly deposited collagen (Figure 3). The damage is usually not apparent in every acinus and vein, except in severe cases. The degree of hepatocellular necrosis correlates with the height of serum enzyme elevations and time of peak ischemic necrosis. While patients can recover from acute sinusoidal obstruction syndrome, reported long term outcomes include cirrhosis and nodular regeneration, particularly with chronic exposure to toxins or cytotoxic agents.

## Histologic Images

Photomicrographs by

David E. Kleiner, MD, PhD

Laboratory of Pathology

National Cancer Institute

(See high resolution images)

Sinusoidal Obstruction Syndrome

Histologic Features to Note:

This biopsy was taken from a 48 year old man who developed signs of sinusoidal obstruction syndrome following bone marrow transplantation. There is congestion and hemorrhage in zone 3 with spillage of red blood cells in between hepatocytes. This change is associated with hepatocyte necrosis (arrow). The central vein is not clearly seen, but the location is indicated (V). The portal area (P) is also marked for reference.

(See high resolution image)

Sinusoidal Obstruction Syndrome: This biopsy was taken from a 48 year old man who developed signs of sinusoidal obstruction syndrome following bone marrow transplantation. There is congestion and hemorrhage in zone 3 with spillage of red blood cells in between hepatocytes. This change is associated with hepatocyte necrosis (arrow). The central vein is not clearly seen, but the location is indicated (V). The portal area (P) is also marked for reference.

Sinusoidal Obstruction Syndrome

Histologic Features to Note:

Here a central vein (V) is clearly seen. There is hemorrhage in the vein wall and narrowing of the lumen by loose connective tissue.

(See high resolution image)

Sinusoidal Obstruction Syndrome: Here a central vein (V) is clearly seen. There is hemorrhage in the vein wall and narrowing of the lumen by loose connective tissue.

Sinusoidal Obstruction Syndrome

Histologic Features to Note:

On a Masson trichrome stain, the distinction between the original vein wall (stained blue) and the red colored strands of collagen within the vein lumen (V). In this section, the vessel lumen is almost completely occluded.

(See high resolution image)

Sinusoidal Obstruction Syndrome: On a Masson trichrome stain, the distinction between the original vein wall (stained blue) and the red colored strands of collagen within the vein lumen (V). In this section, the vessel lumen is almost completely occluded.

## Selected References

Zimmerman HJ. Veno-occlusive disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 354-6. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; provides an overview of the history, clinical features, histology and outcome of veno-occlusive disease).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 631-62. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2007; discusses the clinical features, diagnosis and pathogenesis of sinusoidal obstruction syndrome).
Willmot FC, Robertson GW. (1920). Senecio disease, or cirrhosis of the liver due to senecio poisoning. Lancet. (Outbreaks of a severe and often fatal disease presenting with abdominal pain and ascites among Europeans of poorer classes in South Africa were linked to eating wheat contaminated with seeds of Senecio plants which grow as weeds; a similar condition occurred in livestock and was reproduced in guinea pigs and rats).
Bras G, Jeliffe DB, Stuart KL. (1954). Veno-occlusive disease of the liver with nonportal type of cirrhosis occurring in Jamaica. Arch Pathol. (Description of 100 Jamaican-born patients, many infants and children, with liver disease marked by ascites, hepatomegaly and cirrhosis with histological findings of centrolobular congestion and collagen around occluded central veins, often with a history of drinking "bush tea").
Reed GB, Cox AJ. (1966). The human liver after radiation injury: a form of veno-occlusive disease. Am J Pathol. (Description of liver tissue from 12 patients with metastatic tumors who had received 3,000-5,900 rads of irradiation to the liver [5 also received alkylating agents]; early changes were centrolobular congestion, followed by central vein lesions and then occlusion and hepatic cell loss, consistent with a veno-occlusive process involving small branches of hepatic veins).
Tandon BN, Tandon HD, Tandon RK, Narndranathan M, Joshi YK. (1976). An epidemic of veno-occlusive disease of liver in central India. Lancet. (Description of outbreak of 67 cases of veno-occlusive disease [ascites with only mild jaundice and no variceal hemorrhage] among 286 persons in 4 affected villages in central India, apparently due to contamination of wheat with seeds of Crotalaria species).
Shulman HM, McDonald GB, Matthews D, Doney KC, Kopecky KJ, Gauvreau JM, Thomas ED. (1980). An analysis of hepatic venocclusive disease and centrilobular hepatic degeneration following bone marrow transplantation. Gastroenterology. (Analysis of liver biopsies from 204 patients who had undergone bone marrow transplantation for various malignancies, finding veno-occlusive disease in 27 patients, early lesions being centrilobular congestion, hepatocyte degeneration and subintimal edema within small central venules and later lesions fibrous obliteration of central venule lumina and fibrosis; correlated with more aggressive conditioning regimens).
Erichsen C, Jönsson PE. (1984). Veno-occlusive liver disease after dacarbazine therapy (DTIC) for melanoma. J Surg Oncol. (46 year old man with malignant melanoma developed abdominal pain and ascites after a third cycle of dacarbazine [bilirubin 3.1 mg/dL ALT 5282 U/L, Alk P 534 U/L, prothrombin index 12%] and died within days; autopsy showed veno-occlusive disease with eosinophilic infiltrates).
McDonald GB, Sharma P, Matthews DE, Shulman HM, Thomas ED. (1985). The clinical course of 53 patients with venocclusive disease of the liver after marrow transplantation. Transplantation. (Among 255 patients undergoing bone marrow transplantation [now referred to as hematopoietic cell transplantation] for malignant disease, 53 [21%] developed veno-occlusive disease, marked by weight gain [93%] starting ~6 days after transplant followed by jaundice [98%: bilirubin 3.6-29.4 mg/dL], abdominal pain [75%], liver enlargement [68%]; 24 [45%] had serious progressive disease with ascites and hepatic encephalopathy and 17 [32%] died).
Brugieres L, Hartmann O, Benhamou E, Zafrani ES, Caillaud JM, Patte C, Kalifa C, et al. (1988). Veno-occlusive disease of the liver following high-dose chemotherapy and autologous bone marrow transplantation in children with solid tumors: incidence, clinical course and outcome. Bone Marrow Transplant. (Among 173 children undergoing 236 courses of high dose chemotherapy and hematopoietic cell transplantation, 39 children had hepatic abnormalities and 11 met the criteria for having veno-occlusive disease; syndrome marked by weight gain [decrease in sodium excretion] with weight gain of 5-12% followed by hepatomegaly and jaundice [bilirubin 4.5-26.9 mg/dL, ALT 60-1850 U/L, Alk P 1.5-2.5 times ULN]; 4 patients [2%] died).
McDonald GB, Hinds MS, Fisher LD, Schoch HG, Wolford JL, Banaji M, Hardin BJ, et al. (1993). Veno-occlusive disease of the liver and multiorgan failure after bone marrow transplantation: a cohort study of 355 patients. Ann Intern Med. (Prospective analysis of 355 patients undergoing hematopoietic cell transplantation; veno-occlusive disease developed in 54% and was severe in 16%, higher rates were associated with the combination of busulfan with cyclophosphamide [32%] and with total body irradiation [23%]; mortality rate being 98% in those with severe injury).
Giles GJ, Kantarjian HM, Kornblau SM, Thomas DA, Garcia-Manero G, Waddelow TA, Dvid CL, et al. (2001). MyltotargTM (gemtuzumab ozogamicin) therapy is associated with hepatic venoocclusive disease in patients who have not received stem cell transplantation. Cancer. (Among 1119 patients with acute myeloid leukemia treated with gemtuzumab [calciheamicin-conjugated monoclonal anti-CD33], liver injury consistent with sinusoidal obstruction occurred in 14 [12%] 3 to 35 days after first dose, some of whom received no other cytotoxic agents; fatal outcome in 12 patients [10%]).
DeLeve LD, Shulman HM, McDonald GB. (2002). Toxic injury to hepatic sinusoids: sinusoidal obstruction syndrome. Semin Liver Dis. (Review of clinical features, pathology, etiology, prevention and treatment of sinusoidal obstruction syndrome, a better term for this condition than veno-occlusive disease; first described in association with exposure to phytotoxins (pyrrolizidine alkaloids), the most common cause now is cancer chemotherapy and particularly myeloablative conditioning regimens in preparation for hematopoietic cell transplantation).
Gooley TA, Rajvanshi P, Schoch HG, McDonald GB. (2005). Serum bilirubin levels and mortality after myeloablative allogeneic hematopoietic cell transplantation. Hepatology. (Among 1419 patients undergoing bone marrow transplantation, nonrelapse mortality was 30% by day 200 and correlated with height of bilirubin and presence of multiorgan failure).
McDonald GB. (2006). Review article: management of hepatic disease following haematopoietic cell transplant. Aliment Pharmacol Ther. (Sinusoidal obstruction syndrome arises in first 20-30 days after hematopoietic cell transplant, case fatality rate is 15-20%, frequency ~38%, but frequency varies by risk factors [cyclophosphamide pharmacokinetics, preexisting liver disease, irradiation dose and use of gemtuzumab], no therapy has proven efficacious but defibrotide and repletion of glutathione deserve evaluation).
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their cause and means of prevention; the rate of sinusoidal obstruction syndrome has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high dose cyclophosphamide], better understanding of pharmacokinetics of the alkylating agents, and lower frequency of hepatitis C in marrow recipients).
Richardson PG, Soiffer RJ, Antin JH, Uno H, Jin Z, Kurtzberg J, Martin PL, et al. (2010). Defibrotide for the treatment of severe hepatic veno-occlusive disease and multiorgan failure after stem cell transplantation: a multicenter, randomized, dose-finding trial. Biol Blood Marrow Transplant. (Trial of two doses of intravenous defibrotide in 149 patients with severe veno-occlusive disease after stem cell transplantation; 100 day survival was 42% with no differences between the two doses).